# Gonadotropin Releasing Hormone (GnRH) Analogues

## OVERVIEW

### Introduction

The gonadotropin releasing hormone (GnRH) agonists and antagonists are short peptide analogues of GnRH that cause a profound inhibition of estrogen and androgen synthesis and are used predominantly as androgen deprivation therapy of advanced prostate cancer. Some of these agents are also used to treat benign conditions responsive to hormonal inhibition such as endometriosis, uterine fibroids, precocious puberty and infertility. Leuprolide, goserelin, triptorelin and histrelin are considered GnRH agonists, whereas degarelix acts predominantly as an antagonist. Several of the GnRH analogues have been reported to be associated with transient serum enzyme elevations during therapy, but none have been convincingly implicated in causing clinically significant liver injury with jaundice.

### Background

Gonadotropin releasing hormone is a decapeptide that is produced in the hypothalamus and acts upon GnRH receptors on the surface of gonadotropin cells in the pituitary gland, stimulating the release of luteinizing hormone (LH) and follicular stimulating hormone (FSH) which, in turn, stimulate the production and release of testosterone by the male testes and estrogen by the female ovaries and placenta. GnRH is typically produced in a pulsatile manner, and its synthesis is regulated by circulating levels of testosterone in men and estrogens in women. Infusions of GnRH agonists produce an initial transient increase in sex hormones, but with continued non-pulsatile stimulation, LH and FSH synthesis are inhibited and estrogen and testosterone levels decline. GnRH analogues have been found to be much more potent and sustained in action that the native decapeptide and have been used extensively in modulation of sex hormone synthesis. The GnRH analogue degarelix acts in a somewhat different manner in that it is an antagonist of the gonadotropin receptors in the pituitary and inhibit LH and FSH synthesis and release directly, and without an initial surge that is typical of the GnRH agonists. The ultimate effects and efficacy of the GnRH agonists and antagonist are similar, the difference being a more rapid onset and the lack of an initial surge in sex hormone release with the pure antagonist.

The commercial names and year of approval in the United States of the currently available forms of GnRH agonists and antagonists are: leuprolide, also called leuprorelin (Lupron: 1985), goserelin (Zoladex: 1989), histrelin (Supprelin, Vantas: 1991 and 2004), triptorelin (Trelstar: 2000), degarelix (Firmagon: 2008), and relugolix (Orgovyk: 2021). Many of these agents are now available in generic forms as well. Long acting forms that allow for administration at 1, 3, 6 and even 12-month intervals are available for some GnRH analogues. The GnRH analogues all require parenteral (subcutaneous or intramuscular) administration and are used largely as androgen deprivation therapy for advanced prostate cancer. They are used off-label for precocious puberty, gender dysphoria and infertility.

Common side effects of the GnRH agonists and antagonists include symptoms of hypogonadism such as hot flashes, gynecomastia, fatigue, weight gain, fluid retention, erectile dysfunction and decreased libido. Long term therapy can result in metabolic abnormalities, weight gain, worsening of diabetes and osteoporosis. Rare, but potentially serious adverse events include transient worsening of prostate cancer due to surge in testosterone with initial injection of GnRH agonists and pituitary apoplexy in patients with pituitary adenoma. Single instances of clinically apparent liver injury have been reported with some GnRH agonists (histrelin, goserelin), but the reports were not very convincing. There is no evidence to indicate that there is cross sensitivity to liver injury among the various GnRH analogues despite their similarity in structure.

Five GnRH analogues are discussed separately with specific references to their safety and hepatotoxicity at the end of each section. General references are given below.

Drug Class: Antineoplastic Agents; Obstetrical and Gynecological Agents

GnRH Analogues: Degarelix, Goserelin, Histrelin, Leuprolide, Relugolix, Triptorelin

## ANNOTATED BIBLIOGRAPHY

References updated: 20 March 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999, before the availability of GnRH analogues).
DeLeve LD. Hormones. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 699. (Review of hepatotoxicity published in 2007; the GnRH analogues are not discussed).
Moy B, Lee RJ, Smith M. Gonadotrophin-releasing hormone agonists and antagonists. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman.s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1764. (Textbook of pharmacology and therapeutics).
Maillefert JF, Sibilia J, Kuntz JL, Tavernier C. (1994). Gonadotrophin-releasing hormone agonists induce osteoporosis. Br J Rheumatol. (58 and 69 year old men with prostate cancer were treated with leuprolide for 3 years and triptorelin for 9 months when they presented with back pain and vertebral fractures, which were not present on pretreatment imaging).
Hands KE, Alvarez A, Bruder JM. (2007). Gonadotropin-releasing hormone agonist-induced pituitary apoplexy in treatment of prostate cancer: case report and review of literature. Endocr Pract. (Review of 7 cases of pituitary apoplexy occurring after initiation of GnRH agonist therapy for prostate cancer).
Guerra Y, Lacuesta E, Marquez F, Raksin PB, Utset M, Fogelfeld L. (2010). Apoplexy in non functioning pituitary adenoma after one dose of leuprolide as treatment for prostate cancer. Pituitary. (60 year old man with prostate cancer developed headaches and neurologic symptoms within 24 hours of a first injection of leuprolide, and subsequent evaluation revealed a previously unsuspected nonfunctioning pituitary adenoma).
Boccon-Gibod L, van der Meulen E, Persson BE. (2011). An update on the use of gonadotropin-releasing hormone antagonists in prostate cancer. Ther Adv Urol. (GnRH antagonists such as degarelix have similar efficacy to GnRH agonists in therapy of prostate cancer, but have a more rapid onset of action and do not cause the initial testosterone surge that occurs with the agonists, which can be particularly troublesome in patients with a large tumor burden).
Duburque C, Bonnal JL, Gosset P, Lucidarme D. (2012). Prog Urol. (59 year old man with prostate cancer and heavy alcohol intake [80 g daily] developed jaundice 6 weeks after stopping bicalutamide and 10 days after a 2nd every-12-week injection of goserelin [bilirubin 21.3 mg/dL, ALT 50 times ULN, Alk P 2 times ULN, ANA 1:640, MCV 105], resolving 4 months after onset).
Van Poppel H, Klotz L. (2012). Gonadotropin-releasing hormone: an update review of the antagonists versus agonists. Int J Urol. (Review of androgen deprivation therapy for prostate cancer using GnRH agonists and antagonists stressing the more rapid onset of action and similar if not better safety profile of GnRH antagonists).
Walker LM, Tran S, Robinson JW. (2013). Luteinizing hormone--releasing hormone agonists: a quick reference for prevalence rates of potential adverse effects. Clin Genitourin Cancer. (Systematic review of adverse event profile of long term use of GnRH agonists which mostly relate to hypogonadism: hot flashes, gynecomastia, genital shrinkage, hair loss, osteoporosis, mild anemia, hyperglycemia, increased weight, loss of skeletal muscle mass, emotional lability, depression, loss of sexual desire and erectile dysfunction; no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to a GnRH analogue).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e.7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to a GnRH analogue)
Bolton EM, Lynch TH. (2018). Are all gonadotropin-releasing hormone agonists equivalent for the treatment of prostate cancer? A systematic review. BJU Int. (Systematic review of literature on relative efficacy and safety of different GnRH agonists, indicates that there is little evidence of superiority of any of the four, largely because of lack of adequately powered, controlled studies comparing them).